# Muromonab-CD3

## OVERVIEW

### Introduction

Muromonab-CD3 is a mouse monoclonal antibody to CD3, often referred to as OKT3, which was withdrawn from use in 2010 but was previously used to treat acute cellular rejection after solid organ transplantation. Muromonab has been linked to mild and transient serum enzyme elevations during therapy, but has not been linked to cases of clinically apparent liver injury. Muromonab is a potent immunosuppressive agent and might result in reactivation of hepatitis B in susceptible patients.

### Background

Muromonab (mue” roe moe’ nab) is a mouse monoclonal immunoglobulin G2 antibody to CD3, a cell surface receptor found on T cells. Engagement of the receptor leads to T cell activation, but without secondary signals the binding results in blockage and T cell apoptosis. Infusions of muromonab lead to depletion of T cells and decrease in T cell activity which is the major cause of acute cellular rejection. Muromonab was approved for use in treating acute rejection after renal transplantation in 1985 and its indications were later broadened to include rejection after heart and liver transplantation. Muromonab was the first monoclonal antibody approved for use in humans and was widely used to treat acute rejection until safer biologics with similar activities that were humanized or fully human monoclonal antibodies. Because of the frequency of severe adverse reactions including cytokine storms syndrome, muromonab was withdrawn by its sponsor in 2010. Muromonab had also been used off label to prevent cellular rejection, given as induction therapy before and/or early after transplantation. The name “muromonab” represents a shortened form of “murine monoclonal antibody” and was assigned before the official WHO nomenclature for monoclonal antibodies was introduced. Muromonab-CD3 was previously available in liquid solution in 5 mL ampules of 5 mg under the brand name Orthoclone OKT3. The usual regimen in adults was 5 mg intravenously each day for 10 to 14 days. The pediatric dose (<30 kg) was 2.5 mg daily. Adverse events were common during muromonab therapy, but many were probably due to the underlying condition and other complications of organ transplantation. Muromonab is a mouse monoclonal antibody and hypersensitivity reactions and development of inactivating antibodies occurred not infrequently with its use. Furthermore, the initial engagement of CD3 receptors can result in a transient, acute release of proinflammatory cytokines (cytokine release syndrome) with symptoms of high fever, weakness, dyspnea, nausea, chest pain and diarrhea arising within the first two days of starting therapy. Less common, but potentially severe adverse reactions after muromonab therapy included bacterial and opportunistic infections, reactivation of viral infections (EBV, HSV, CMV, HBV, RSV, among others), acute thromboses, and malignancies, particularly EBV-associated lymphoproliferative disorders.

### Hepatotoxicity

When given as a part of induction therapy for solid organ transplantation, muromonab was linked to a low rate of transient serum enzyme elevations, which was similar to that which can occur with standard therapy. The serum enzyme elevations were generally mild-to-moderate and resolved spontaneously. Muromonab induction therapy was not been linked to instances of clinically apparent liver injury. Administration of muromonab as treatment of acute cellular rejection was commonly associated with acute infusion reactions, but was not convincingly linked to acute liver injury.

Muromonab is a potent immunosuppressive agent and may be capable of causing reactivation of chronic hepatitis B. However, when used in prevention of organ rejection, it was not linked to cases of reactivation, perhaps because patients at risk are routinely given prophylaxis and the role of muromonab versus other rejection medications (cyclosporine, tacrolimus, corticosteroids) was not clear.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Transplant Agents, Monoclonal Antibodies

Other Drugs in the Subclass, Monoclonal Antibodies: Alemtuzumab, Basiliximab, Daclizumab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Muromonab-CD3 – Orthoclone OKT3®

DRUG CLASS

Transplant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Muromonab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Muromonab-CD3 | 140608-64-6 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 28 December 2020

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents mentions muromonab and problems of reactivation of hepatitis).
Krensky AM, Azzi JR, Hafler DA. Immunosuppressants and toleragens. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 637-53. (Textbook of pharmacology and therapeutics).
Ortho Multicenter Transplant Study Group. (1985). A randomized clinical trial of OKT3 monoclonal antibody for acute rejection of cadaveric renal transplants. N Engl J Med. (Among 123 patients with acute rejection after renal transplantation, 94% of muromonab [OKT3] vs 75% of high dose methylprednisolone recipients had reversal of the acute rejection; adverse events included acute infusion reactions [fever, chills, tremor, dyspnea, chest tightness, wheezing and nausea], no mention of ALT elevations).
Richards JM, Vogelzang NJ, Bluestone JA. (1990). Neurotoxicity after treatment with muromonab-CD3. N Engl J Med. (Among 13 patients treated with muromonab for refractory solid tumors, 11 developed signs of neurotoxicity, some with culture negative cerebral spinal fluid pleocytosis, all resolving rapidly with symptomatic therapy).
Swinnen LJ, Costanzo-Nordin MR, Fisher SG, O'Sullivan EJ, Johnson MR, Heroux AL, Dizikes GJ, et al. (1990). Increased incidence of lymphoproliferative disorder after immunosuppression with the monoclonal antibody OKT3 in cardiac-transplant recipients. N Engl J Med. (Retrospective analysis found that 9 of 79 [9%] heart transplant recipients treated with muromonab vs 1 of 75 who did not receive muromonab developed posttransplant lymphoproliferative disorder).
Claesson K, Tufveson G, Wahlberg J. (1992). Treatment with poly- and monoclonal antilymphocyte antibodies: assessment of efficacy and safety in transplantation. Transplant Proc. (Among 145 patients undergoing organ transplantation, graft survival and adverse events were similar in those who received antibody therapy of rejection and those who did not; no mention of ALT elevations or hepatotoxicity).
Norman DJ, Kahana L, Stuart FP, Thistlethwaite JR, Shield CF, Monaco A, Dehlinger J, et al. (1993). A randomized clinical trial of induction therapy with OKT3 in kidney transplantation. Transplantation. (Among 215 patients undergoing renal transplantation, use of muromonab as induction therapy was associated with fewer rejection episodes [51% vs 66%] and marginally improved graft-, but similar patient-survival; adverse events were more common with muromonab than conventional therapy, but were largely due to early infusion reactions [with fever, tachycardia, nausea and hypotension] and viral infections [herpes, CMV]; no mention of ALT elevations or hepatotoxicity).
van Gelder T, Balk AH, Jonkman FA, Zietse R, Zondervan P, Hesse CJ, Vaessen LM, et al. (1996). A randomized trial comparing safety and efficacy of OKT3 and a monoclonal anti-interleukin-2 receptor antibody (BT563) in the prevention of acute rejection after heart transplantation. Transplantation. (Among 60 patients undergoing heart transplantation randomized to receive either muromonab or a mouse monoclonal antibody to the IL2 receptor, infusion reactions were more common, and acute rejection episodes were delayed, but similar in frequency among the muromonab recipients; no mention of ALT elevations or hepatotoxicity).
(1998). New monoclonal antibodies to prevent transplant rejection. Med Lett Drugs Ther. (Concise review of the efficacy and safety of basiliximab and daclizumab, two monoclonal antibodies to the IL2 receptor, shortly after their approval for use in transplantation in the US; mentions that muromonab has been used for many years for treatment of transplant rejection and is used with some success to prevent rejection; no mention of ALT elevations or hepatotoxicity).
Midtvedt K, Fauchald P, Lien B, Hartmann A, Albrechtsen D, Bjerkely BL, Leivestad T, et al. (2003). Individualized T cell monitored administration of ATG versus OKT3 in steroid-resistant kidney graft rejection. Clin Transplant. (Among 55 patients undergoing renal transplantation treated with variable doses of either ATG or muromonab based upon T cell counts, rejection rates were similar as were adverse events; no mention of ALT elevations or hepatotoxicity).
Sellers MT, McGuire BM, Haustein SV, Bynon JS, Hunt SL, Eckhoff DE. (2004). Two-dose daclizumab induction therapy in 209 liver transplants: a single-center analysis. Transplantation. (Among 352 liver transplant recipients, the 209 who received daclizumab induction therapy had lower rates of acute rejection [25% vs 39%] and hepatitis C recurrent rates were similar; no mention of hepatotoxicity).
Morris JA, Hanson JE, Steffen BJ, Chu AH, Chi-Burris KS, Gotz VP, Gordon RD. (2005). Daclizumab is associated with decreased rejection and improved patient survival in renal transplant recipients. Clin Transplant. (Analysis of SRTR database on renal transplant recipients receiving daclizumab [n=8203] or no induction treatment [n=25368] in the US between 1998 and 2003 found lower reported rates of rejection [13% vs 17% after 3 years] and improved patient and graft survival, with no excess mortality from malignancy or opportunistic infections).
Chin C, Pittson S, Luikart H, Bernstein D, Robbins R, Reitz B, Oyer P, et al. (2005). Induction therapy for pediatric and adult heart transplantation: comparison between OKT3 and daclizumab. Transplantation. (Comparison of daclizumab [n=40] to muromonab [n=40] as induction therapy to prevent rejection after heart transplantation found no difference in rates of rejection, but higher rates of adverse events with muromonab including infections [33%], anaphylaxis [10%], and single cases of rejection death and acute renal failure [2%]; no mention of ALT elevations or hepatotoxicity).
Segovia J, Rodríguez-Lambert JL, Crespo-Leiro MG, Almenar L, Roig E, Gómez-Sánchez MA, Lage E, et al. (2006). A randomized multicenter comparison of basiliximab and muromonab (OKT3) in heart transplantation: SIMCOR study. Transplantation. (Among 99 patients undergoing heart transplantation given therapy to prevent rejection with either basiliximab or muromonab, side effects were more common with muromonab and included fever [26%], pulmonary edema [10%], hypotension [8%], headache [4%], diarrhea, flushing, itching, confusion syndrome, nausea and vomiting; no mention of ALT elevations or hepatotoxicity).
Cai J, Terasaki PI. (2010). Induction immunosuppression improves long-term graft and patient outcome in organ transplantation: an analysis of United Network for Organ Sharing registry data. Transplantation. (Since 2003, most solid organ transplant recipients have received induction therapy, and analyses of the UNOS registry for this period shows highest rates of patient and graft survival with alemtuzumab [89% 5 year patient survival] as compared to antithymocyte globulin [89%], basiliximab [84%], daclizumab [77%], steroids [75%] or no induction [71%]).
Melis M, Biagi C, Småbrekke L, Nonino F, Buccellato E, Donati M, Vaccheri A, et al. (2015). Drug-induced progressive multifocal leukoencephalopathy: a comprehensive analysis of the WHO adverse drug reaction database. CNS Drugs. (Among 2452 reports of progressive multifocal leukoencephalopathy submitted to the WHO Adverse Drug Database as of 2014, 343 different drugs were implicated, most commonly natalizumab [n=618], rituximab [519], methotrexate [244], cyclophosphamide [215], fludarabine [152], vincristine [125], prednisone [110] and mycophenolic acid [109], but also muromonab [12], basiliximab [4] and antithymocyte globulin [10]).

## OTHER REFERENCE LINKS

1 Recent References on Muromonab-CD3: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Muromonab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Muromonab-CD3: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Muromonab)